# Dipeptidyl Peptidase-4 Inhibitors

## OVERVIEW

The dipeptidyl peptidase 4 (DPP-4) inhibitors are a family of diabetic agents that enhance glucagon-like peptide-1 (GLP-1) activity, a gastrointestinal hormone (incretin) that increases glucose dependent insulin secretion. The DPP-4 inhibitors decrease the degradation of GLP-1 and thereby increase endogenous circulating levels. The increase levels of GLP-1 in the circulation increase pancreatic insulin secretion and improve glycemic control in patients with type 2 diabetes. The DPP-4 inhibitors have only recently been introduced into clinical use and the full range of adverse events may not be fully known. However, in prelicensure clinical trials, sitagliptin, saxagliptin, linagliptin and alopgliptin, the first four DPP-4 inhibitors to receive FDA approval in the United States, were not associated with an increase in serum aminotransferase or alkaline phosphatase elevations above the rates found in controls, and no clinically apparent acute liver injury was reported. Since licensure, isolated case reports of liver injury have arisen but liver injury from these agents appears to be rare and generally mild.

As of 2018, the four DPP-4 inibitors that are available in the United States include (with brand names and year of approval): sitagliptin (Januvia, 2006), saxagliptin (Onglyza, 2009), linagliptin (Tradjenta, 2011) and alogliptin (Nesina, 2013). These four DPP-4 inhibitors are discussed individually in LiverTox, but references to their safety and potential hepatotoxicity are given together after this introductory section. DDP-4 inhibitors in clinical use in other countries include vildagliptin, gemigliptin, anagliptin, omarigliptin, evogliptin, gosogliptin and teneligliptin.

The four DDP-4 inhibitors have been linked to rare instances of self-limited, cholestatic or mixed liver injury that generally arises 1 to 4 weeks after initiation of therapy and resolves without residual injury within 1 to 3 months.

Drug Class: Antidiabetic Agents

Drugs in the Subclass Incretin-Based Drugs, DPP-4 Inhibitors: Alogliptin, Linagliptin, Saxagliptin, Sitagliptin

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Alogliptin | 850649-62-6 | C18-H21-N5-O2.C7-H6-O2 | Alogliptin chemical structure
Linagliptin | 668270-12-0 | C25-H28-N8-O2 | Linagliptin Chemical Structure
Saxagliptin | 945667-22-1 | C18-H25-N3-O2.H2O | Saxagliptin Chemical Structure
Sitagliptin | 486460-32-6 | C16-H15-F6-N5-O | Sitagliptin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 03 January 2018

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 575-9. (Textbook of hepatotoxicity published in 1999 and before the availability of sitagliptin and other DPP-4 inhibitors).
De Marzio DH, Navarro VJ. Antidiabetic drugs. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 528-32. (Review of hepatotoxicity of drugs for diabetes mentions that there have been two case reports of liver injury attributed to sitaglitin but none for linagliptin or saxagliptin).
Powers AC, D'Alessio D. Therapy of diabetes. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1248-67 (Textbook of pharmacology and therapeutics).
Amori RE, Lau J, Pittas AG. Efficacy and safety of incretin therapy in type 2 diabetes: systematic review and meta-analysis. JAMA 2007; 298: 194-206. (Systematic review of 29 controlled trials of incretin therapy [exenatide, liraglutide, sitagliptin and vildagliptin], concluding that they have "modest efficacy" but were well tolerated, with few side effects occurring more frequently than in controls and no mention of ALT levels or hepatotoxicity). 17622601
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver injury in the US collected from 2004 to 2008, none were attributed DPP-4 inhibitors which were rarely used during the period of this study). 18955056
Gross BN, Cross LB, Foard J, Wood Y. Elevated hepatic enzymes potentially associated with sitagliptin. Ann Pharmacother 2010; 44: 394-5. (58 year old man with suspected nonalcoholic fatty liver disease developed asymptomatic liver test elevations 1 month after starting sitagliptin [ALT 127 U/L, bilirubin and Alk P normal], which fell upon withdrawal [to 90 U/L after 1 and 62 U/L after 6 months]). 20103614
Fakhoury WK, Lereun C, Wright D. A meta-analysis of placebo-controlled clinical trials assessing the efficacy and safety of incretin-based medications in patients with type 2 diabetes. Pharmacology 2010; 86: 44-57. (Review of safety and efficacy of sitagliptin in 11 controlled trials; no mention of ALT levels or hepatotoxicity). 20616619
Lam S, Saad M. Saxagliptin: a new dipeptidyl peptidase-4 inhibitor for type 2 diabetes. Cardiol Rev 2010; 18: 213-7. (Review of mechanism of action, pharmacology, clinical efficacy and safety of saxagliptin; side effects are usually mild and similar in frequency to placebo; no mention of ALT levels or hepatotoxicity). 20539105
Seck T, Nauck M, Sheng D, Sunga S, Davies MJ, Stein PP, Kaufman KD, Amatruda JM; Sitagliptin Study 024 Group. Safety and efficacy of treatment with sitagliptin or glipizide in patients with type 2 diabetes inadequately controlled on metformin: a 2-year study. Int J Clin Pract 2010; 64: 562-76. (Controlled trial comparing addition of sitagliptin vs glipizide to metformin in 1172 patients with diabetes with 2 year follow up; there were no differences in rates of ALT elevations between the two groups, but rates were not given). 20456211
Williams-Herman D, Engel SS, Round E, Johnson J, Golm GT, Guo H, Musser BJ, et al. Safety and tolerability of sitagliptin in clinical studies: a pooled analysis of data from 10,246 patients with type 2 diabetes. BMC Endocr Disord 2010; 10: 7. (Pooled analysis of safety of sitagliptin in 10,245 patients [19 studies] with diabetes treated for 12 weeks to 2 years; ALT above 3 times ULN occurred in 0.5% [1.5 per 100 patient-years] of sitagliptin vs 0.4% [1.4 per 100] on comparative agents; no mention of clinically apparent liver injury). 20412573
Neumiller JJ, Wood L, Campbell RK. Dipeptidyl peptidase-4 inhibitors for the treatment of type 2 diabetes mellitus. Pharmacotherapy 2010; 30: 463-84. (Systematic review of literature on safety and efficacy of DPP-4 inhibitors; rates of serum enzyme elevations were similar in DPP-4 vs control treated patients, although enzyme elevations have been listed as an adverse event based on postmarketing reporting). 20411998
Toyoda-Akui M, Yokomori H, Kaneko F, Shimizu Y, Takeuchi H, Tahara K, Motoori T, et al. A case of drug-induced hepatic injury associated with sitagliptin. Intern Med 2011; 50: 1015-20. (58 year old man developed jaundice 1 month after starting sitagliptin [bilirubin 11.8 rising to 20.5 mg/dL, ALT 1653 U/L, Alk P 814 U/L, HCV RNA and anti-HCV positive], resolving within 1-2 months; did not exclude acute hepatitis C). 21532224
Linagliptin (Tradjenta): a new DPP-4 inhibitor for type 2 diabetes. Med Lett Drugs Ther 2011; 53 (1367): 49-50. (Concise review of efficacy and safety of linagliptin shortly after its approval; no mention of hepatotoxicity, but 8 of 487 patients on linagliptin developed pancreatitis, compared to none of 1183 on placebo). 21701440
Scott LJ. Linagliptin: in type 2 diabetes mellitus. Drugs 2011; 71: 611-24. (Summary of structure, pharmacology, clinical efficacy and tolerability of linagliptin, a new DPP-4 inhibitor; tolerab ility was similar to other groups including placebo and "there were no clinically significant changes in laboratory parameters"). 21443284
Taskinen MR, Rosenstock J, Tamminen I, Kubiak R, Patel S, Dugi KA, Woerle HJ. Safety and efficacy of linagliptin as add-on therapy to metformin in patients with type 2 diabetes: a randomized, double-blind, placebo-controlled study. Diabetes Obes Metab 2011; 13: 65-74. (Controlled trial of 24 week course of linagliptin vs placebo in 701 patients; "The analysis of laboratory variables...did not reveal any clinically significant findings"). 21114605
Arase Y, Suzuki F, Kobayashi M, Suzuki Y, Kawamura Y, Matsumoto N, Akuta N, et al. Efficacy and safety in sitagliptin therapy for diabetes complicated by chronic liver disease caused by hepatitis C virus. Hepatol Res 2011; 41: 524-9. (Controlled trial of sitagliptin vs placebo in 32 patients with diabetes and chronic hepatitis C showed no change in mean ALT levels during 48 weeks of treatment in either group). 21435130
Drugs for type 2 diabetes. Treat Guidel Med Lett 2011; 9 (108): 47-54. (Concise overview on the use of medications in diabetes). 21778966
Mikhail N. Safety of dipeptidyl peptidase 4 inhibitors for treatment of type 2 diabetes. Curr Drug Saf 2011; 6: 304-9. (Review of the safety of the DPP-4 inhibitors, discussed pancreatitis, but not liver injury). 22424537
Monami M, Dicembrini I, Martelli D, Mannucci E. Safety of dipeptidyl peptidase-4 inhibitors: a meta-analysis of randomized clinical trials. Curr Med Res Opin 2011; 27 Suppl 3:57-64. (Metaanalysis of 53 trials enrolling 30,312 patients on DPP-4 inhibitors and 13,569 on comparator agents, found no differences in rates of cancer, pancreatitis or major cardiovascular events; no mention of liver injury). 22106978
Richard KR, Shelburne JS, Kirk JK. Tolerability of dipeptidyl peptidase-4 inhibitors: a review. Clin Ther 2011; 33: 1609-29. (Systematic review of literature on tolerability of DPP inhibitors found 45 clinical trials of 1 to 104 weeks of therapy; common side effects were headache, gastrointestinal symptoms and pain; no mention of ALT elevations or liver injury). 22071236
Jeong KH, Yoo BK. The efficacy and safety of liraglutide. Int J Clin Pharm 2011; 33: 740-9. (Systematic review of literature on liraglutide, a long acting GLP analogue, found discontinuation rates because of adverse events in 2-12% of liraglutide vs 2-13% of comparator agents; no mention of hepatic toxicity). 21952951
Neumiller JJ. Pharmacology, efficacy, and safety of linagliptin for the treatment of type 2 diabetes mellitus. Ann Pharmacother 2012; 46: 358-67. (Review of the pharmacology, efficacy and safety of linagliptin; pancreatitis occurred in 8 of 4687 linagliptin recipients compared to none of 1183 controls; no mention of liver injury and linapliptin is said to have low propensity for drug interactions). 22318932
Park H, Park C, Kim Y, Rascati KL. Efficacy and safety of dipeptidyl peptidase-4 inhibitors in type 2 diabetes: meta-analysis. Ann Pharmacother 2012; 46: 1453-69. (Systematic review efficacy and safety of DPP-4 inhibitors based upon published controlled trials; side effects were similar in recipients of DPP-4 inhibitors as placebo controls; no mention of ALT elevations or hepatotoxicity). 23136353
Bergenstal RM, Forti A, Chiasson JL, Woloschak M, Boldrin M, Balena R. Efficacy and safety of taspoglutide versus sitagliptin for type 2 diabetes mellitus (T-emerge 4 trial). Diabetes Ther 2012; 3: 13. (Controlled trial of taspoglutide vs sitagliptin in 666 patients with diabetes for 24 weeks; no mention of ALT elevations or hepatotoxicity). 23138449
Gooßen K, Gräber S. Longer term safety of dipeptidyl peptidase-4 inhibitors in patients with type 2 diabetes mellitus: systematic review and meta-analysis. Diabetes Obes Metab 2012; 14 (12): 1061-72. (Systematic review of controlled trials of DPP-4 inhibitors focusing on long term safety found no evidence of an increase rate of infections; no mention of ALT elevations or hepatotoxicity). 22519906
Lo Re V 3rd, Haynes K, Ming EE, Wood Ives J, Horne LN, Fortier K, Carbonari DM, et al. Safety of saxagliptin: rationale for and design of a series of postmarketing observational studies. Pharmacoepidemiol Drug Saf 2012; 21: 1202-15. (Design of large, retrospective postmarketing studies of saxagliptin aimed at assessing rare adverse reactions including liver injury). 22763953
Seino Y, Miyata Y, Hiroi S, Hirayama M, Kaku K. Efficacy and safety of alogliptin added to metformin in Japanese patients with type 2 diabetes: a randomized, double-blind, placebo-controlled trial with an open-label, long-term extension study. Diabetes Obes Metab 2012; 14: 927-36. (Among 288 patients with type 2 diabetes on metformin who were treated with two doses of alogliptin for up to 52 weeks, ALT elevations occurred in 1.4 and 3.4%, but none were considered "clinically significant"). 22583697
Jarvis CI, Cabrera A, Charron D. Alogliptin: a new dipeptidyl peptidase-4 inhibitor for type 2 diabetes mellitus. Ann Pharmacother 2013; 47: 1532-9. (Systematic review of the efficacy and safety of alogliptin mentions that in multiple controlled studies, "no clinically relevant changes in laboratory assessments" were noted but that, since licensure, cases of pancreatitis, hypersensitivity reactions and fatal and non-fatal hepatic failure have been reported to the sponsor). 24285765
Alogliptin (Nesina) for type 2 diabetes. Med Lett Drugs Ther 2013; 55 (1417): 41-3. (Concise summary of mechanism of action, efficacy and safety of alogliptin shortly after its approval for use in the US mentions that reported severe adverse effects include acute pancreatitis, hypoglycemia, hypersensitivity reactions, Stevens Johnson syndrome and fatal hepatic failure). 23715128
Drugs for type 2 diabetes. Treat Guidel Med Lett 2014; 12 (139): 17-24. (Concise summary of efficacy and safety of drugs for type 2 diabetes and guidelines on their use; listed side effects of the four DPP-4 inhibitors approved for use in the US include hypersensitivity reactions, acute pancreatitis and fatal hepatic failure). 24566424
Seino Y, Yabe D. Alogliptin benzoate for the treatment of type 2 diabetes. Expert Opin Pharmacother 2014; 15: 851-63. (Review of the structure, mechansim of action, pharmacokinetics, efficacy and safety of alogliptin mentions that it is generally well tolerated and that in 13 controlled trials, adverse events were similar in all treatment arms; no specific discussion of hepatotoxicity or ALT levels). 24646052
Kutoh E. Probable linagliptin-induced liver toxicity: A case report. Diabetes Metab 2014; 40: 82-4. (58 year old woman developed fatigue and jaundice 4 weeks after starting linagliptin [peak bilirubin 2.1 mg/dL, ALT 1006, Alk P 2.1 times ULN], with rapid improvement in symptoms, but slow resolution of abnormal enzymes upon stopping). 24378344
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to a DPP-4 inhibitor or other antidiabetic medication). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, but none of the cases were attributed to a DPP-4 inhibitor or other anti-diabetic medication). 24552865
White WB, Cannon CP, Heller SR, Nissen SE, Bergenstal RM, Bakris GL, Perez AT, et al.; EXAMINE Investigators. Alogliptin after acute coronary syndrome in patients with type 2 diabetes. N Engl J Med 2013; 369: 1327-35. (Among 5380 patients with type 2 diabetes and coronary artery disese treated with alogliptin or placebo for a median of 18 months, rates of death and cardiovascular and cerebrovascular events were similar in the two groups, as were rates of serum ALT elevations [2.4% vs 1.7%] and AST elevations [1.8% vs 1.6%] above 3 times ULN). 23992602
Hirshberg B, Parker A, Edelberg H, Donovan M, Iqbal N. Safety of saxagliptin: events of special interest in 9156 patients with type 2 diabetes mellitus. Diabetes Metab Res Rev 2014; 30: 556-69. (Pooled analysis of 20 controlled trials of saxagliptin in 9156 patients with type 2 diabetes found similar rates of severe adverse events and deaths with saxagliptin vs placebo or standard care treatment and similar rates of ALT or AST elevations [1.5% vs 1.3% of patients had values that rose above 3 times ULN]). 24376173
Asakawa M, Mitsui H, Akihisa M, Sekine T, Niitsu Y, Kobayashi A, Miyake A, et al. Efficacy and safety of sitagliptin for the treatment of diabetes mellitus complicated by chronic liver injury. Springerplus. 2015; 4: 346. (Among 122 patients with type 2 diabetes and chronic liver injury treated with sitagliptin for an average of one year, there was a significant decrease in mean HbA1c levels, but no worsening of ALT [decreasing: 75 U/L to 66 U/L] or AST [no changing: 56 U/L to 57 U/L]). 26191473
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 cases [0.5%] were at least possibly attributed to antidiabetic medications including 1 to sitagliptin). 25754159
Lo Re V, Carbonari DM, Saine ME, Newcomb CW, Roy JA, Liu Q, Wu Q, et al. Postauthorization safety study of the DPP-4 inhibitor saxagliptin: a large-scale multinational family of cohort studies of five outcomes. BMJ Open Diabetes Res Care 2017; 5: e000400. (Analysis of patients with diabetes from 4 large health care networks between 2009 and 2014 for adverse events following initiation of therapy with saxagliptin compared to use of other antidiabetic agents found no increased rates of acute liver or kidney failure or severe hypersensitivity reactions). 28878934
Rehman MB, Tudrej BV, Soustre J, Buisson M, Archambault P, Pouchain D, Vaillant-Roussel H, Gueyffier F, et al. Efficacy and safety of DPP-4 inhibitors in patients with type 2 diabetes: Meta-analysis of placebo-controlled randomized clinical trials. Diabetes Metab 2017; 43: 48-58. (Among 36 controlled trials of DPP-4 inhibitors involving 54,664 patients with type 2 diabetes, there was no increase in rates of mortality, myocardial infarction, stroke or renal failure, but slight increase in rates of acute pancreatitis and heart failure). 27745828